# Ivosidenib

## OVERVIEW

### Introduction

Ivosidenib is an orally available small molecule inhibitor of mutated isocitrate dehydrogenase-1 that is used as an antineoplastic agent in the treatment of adults of acute myelogenous leukemia (AML). Ivosidenib is associated with a moderate rate of serum aminotransferase elevations during therapy and is suspected to be the cause of rare instances of clinically apparent acute liver injury.

### Background

Ivosidenib (eye" voe sid' i nib) is an orally available, small molecule inhibitor of isocitrate dehydrogenase-1 (IDH1), an enzyme rearranged and mutated in some forms of leukemia and lymphoma. Isocitrate dehydrogenase is an oxidative decarboxylase which is important in maintaining normal progenitor and stem cell differentiation. Mutation in IDH1 can lead to accumulation of a toxic intermediate (2-hydroxyglutarate; 2-HG) that blocks normal cell differentiation and promotes cancer cell growth. IDH1 mutations are found in 7% to 14% of patients with AML. In cell culture, ivosidenib has been found to decrease 2-HG levels and restore normal cell differentiation in cancer cells with IDH1 mutations. Clinical trials of ivosidenib have demonstrated beneficial objective response rates in adult patients with AML and susceptible IDH1 mutations. Ivosidenib received accelerated approval for use refractory or relapsed AML with mutated IDH1 in the United States in 2018. A specific small molecule inhibitor of IDH2, enasidenib, was approved as therapy of AML with mutations in IDH2 in 2017. These two IDH inhibitors appear to have similar efficacy against their respective mutated enzyme as well as similar adverse effects. The indications for ivosidenib were subsequently expanded to include relapsed or refractory myelodysplastic syndromes and advanced or metastatic, previously treated, cholangiocarcinoma with susceptible IDH1 mutations or rearrangements. Ivosidenib is available in tablets of 250 mg under the brand name Tibsovo. The dose is 500 mg once daily, continued until progressive disease or intolerable toxicity occurs. Side effects are common and can include fatigue, arthralgia, fever, diarrhea, nausea, abdominal pain, dyspnea, cough, peripheral edema, mucositis and rash. Uncommon, but potentially severe side effects include differentiation syndrome, QTc prolongation, Guillain Barre’ syndrome, and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during ivosidenib therapy occurring in 15% to 20% of patients but rising above 5 times the upper limit of the normal range in only 1% to 2%. Ivosidenib has had limited clinical use but has not been linked to instances of acute liver injury with symptoms or jaundice. Because of the limited clinical experience with the use of IDH inhibitors, their potential for causing liver injury is not well defined.

In prelicensure studies, ivosidenib therapy was associated with "differentiation syndrome" in 5% to 20% of patients, which was sometimes severe and life-threatening. Differentiation syndrome is marked by rapid proliferation of myeloid cells and symptoms of respiratory distress, accompanied by hypoxia, pulmonary infiltrates and pleural effusions. Other manifestations include renal impairment, fever, lymphadenopathy, bone pain, peripheral edema and weight gain. Liver dysfunction can also occur but is generally overshadowed by the more severe systemic manifestations. The onset of differentiation syndrome is generally within 2 to 8 weeks of starting therapy and the course can be severe. Management includes stopping ivosidenib and use of corticosteroids and hydroxyurea in more severe cases. Patients can be restarted on ivosidenib once the syndrome resolves.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of the liver injury due to ivosidenib is not known. Ivosidenib is metabolized in the liver largely by the cytochrome P450 system (largely CYP 3A4) and is susceptible to drug-drug interactions with inhibitors or inducers of the microsomal enzyme system. Some serum aminotransferase elevations during ivosidenib therapy may be due to the release of proinflammatory cytokines as a part of the differentiation syndrome.

### Outcome and Management

Ivosidenib therapy has been associated with transient serum aminotransferase elevations during therapy but has not been linked to instances of acute liver injury with jaundice or symptoms. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks or if symptoms or jaundice arise.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other IDH1 and IDH2 Inhibitors: Enasidenib, Olutasidenib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ivosidenib – Tibsovo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Ivosidenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ivosidenib | 1448347-49-6 | C28-H22-Cl-F3-N6-O3 | SID: 313371287

## ANNOTATED BIBLIOGRAPHY

References updated: 06 January 2024

Abbreviation: AML, acute myelogenous leukemia; IDH, Isocitrate dehydrogenase.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 before the availability of ivosidenib and enasidenib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/211192Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Birendra KC, DiNardo CD. Evidence for clinical differentiation and differentiation syndrome in patients with acute myeloid leukemia and IDH1 mutations treated with the targeted mutant IDH1 inhibitor, AG-120. Clin Lymphoma Myeloma Leuk 2016; 16: 460-5. (Three patients with AML and mutant IDH1 who were treated with ivosidenib developed clinically apparent differentiation syndrome during the first two cycles of therapy manifested by neutrophil-predominant leukocytosis, fever, cough, shortness of breath, pulmonary failure, pleural and pericardial effusions; treated successfully with corticosteroids and hydroxyurea which allowed subsequent courses of ivosidenib; no mention of ALT elevations or hepatic involvement). 27245312
Upadhyay VA, Brunner AM, Fathi AT. Isocitrate dehydrogenase (IDH) inhibition as treatment of myeloid malignancies: Progress and future directions. Pharmacol Ther 2017; 177: 123-8. (Review of the role of mutations in IDH-1 and -2 in oncogenesis which act as “oncometabolites” causing accumulation of 2-hydroxyglutarate which inhibits histone demethylases causing epigenetic changes in cellular differentiation genes, factors that make these mutation enzymes promising targets for anticancer therapeutics). 28315358
DiNardo CD, Stein EM, de Botton S, Roboz GJ, Altman JK, Mims AS, Swords R, et al. Durable remissions with ivosidenib in IDH1-mutated relapsed or refractory AML. N Engl J Med 2018; 378: 2386-98. (Among 258 patients with relapsed or refractory, IDH1 mutant AML who were treated with ivosidenib, the overall response rate was 42% and adverse events included diarrhea [21%], leukocytosis [30%], febrile neutropenia [29%], fatigue [26%], dyspnea [25%], QTc prolongation [25%], peripheral edema [22%], anemia [22%], cough [21%] and differentiation syndrome [5%, none fatal], while ALT elevations occurred in 27% of patients, but values were above 5 times ULN in less than 1%). 29860938
Fathi AT, DiNardo CD, Kline I, Kenvin L, Gupta I, Attar EC, Stein EM, de Botton S; AG221-C-001 Study Investigators. Differentiation syndrome associated with enasidenib, a selective inhibitor of mutant isocitrate dehydrogenase 2: analysis of a phase 1/2 study. JAMA Oncol 2018; 4: 1106-10. (Among 281 patients with AML treated with enasidenib [50-650 mg daily] in open label trials, 33 [12%] were judged to have developed differentiation syndrome marked by dyspnea, fever, lung infiltrates and hypoxia with onset after 7-129 days [median 30 days], usually responding to corticosteroid therapy, half requiring dose interruption, none dying acutely, and all able to restart enasidenib after its resolution). 29346478
Norsworthy KJ, Luo L, Hsu V, Gudi R, Dorff SE, Przepiorka D, Deisseroth A, et al. FDA approval summary: ivosidenib for relapsed or refractory acute myeloid leukemia with an isocitrate dehydrogenase-1 mutation. Clin Cancer Res. 2019;25:3205-3209. (Review of the data on safety and efficacy of ivosidenib that supported its approval as therapy of relapsed or refractory AML with mutant IDH1, mentions that adverse events occurred in 99% of patients and included serious cases of differentiation syndrome [13%], QT prolongation [10%], dyspnea [9%], leukocytosis [8%], tumor lysis syndrome [6%], resulting in therapy interruption in 38%, discontinuation 13%; no mention of ALT elevations or hepatotoxicity). 30692099
Abou-Alfa GK, Macarulla T, Javle MM, Kelley RK, Lubner SJ, Adeva J, Cleary JM, et al. Ivosidenib IDH1-mutant, chemotherapy-refractory cholangiocarcinoma (ClarIDHy): a multicentre, randomised, double-blind, placebo-controlled, phase 3 study. Lancet Oncol. 2020;21:796-807. (Among 185 adults with IDH1 mutant, refractory cholangiocarcinoma treated with ivosidenib or placebo, the objective response rate was only 2% vs 0% and progression free survival minimally longer [2.7 vs 1.4 months] while adverse event rates were high, ALT elevations arising in 9% vs 2% and bilirubin elevations in 10% vs 7%). 32416072
DiNardo CD, Stein AS, Stein EM, Fathi AT, Frankfurt O, Schuh AC, Döhner H, et al. Mutant isocitrate dehydrogenase 1 inhibitor ivosidenib in combination with azacitidine for newly diagnosed acute myeloid leukemia. J Clin Oncol. 2021;39:57-65. (Among 23 patients with refractory IDH1 mutant AML treated with ivosidenib and azacytidine, the objective response rate was 71% and all patients had at least one adverse event, most commonly thrombocytopenia, anemia, febrile neutropenia, nausea, diarrhea, constipation, and pyrexia, but there were no treatment related deaths; no mention of ALT elevations or hepatotoxicity). 33119479
Stemer G, Rowe JM, Ofran Y. Efficacy and safety profile of ivosidenib in the management of patients with acute myeloid leukemia (AML): an update on the emerging evidence. Blood Lymphat Cancer. 2021;11:41-54. (Review of the efficacy and safety of ivosidenib does not mention ALT elevations or hepatotoxicity). 34188585
Zhu AX, Macarulla T, Javle MM, Kelley RK, Lubner SJ, Adeva J, Cleary JM, et al. Final overall survival efficacy results of ivosidenib for patients with advanced cholangiocarcinoma with IDH1 mutation: the phase 3 randomized clinical ClarIDHy Trial. JAMA Oncol. 2021;7:1669-1677. (Final survival results from the randomized controlled trial of ivosidenib vs placebo in 187 adults with irresectable or metastatic cholangiocarcinoma with mutant IDH1, provides the overall survival of 10.3 vs 7.5 months with serious treatment related adverse events in 42% vs 24%, including three cases of hyperbilirubinemia during ivosidenib therapy, one of which was considered due to cholestatic hepatitis, but there were no treatment related deaths). 34554208
Woods A, Norsworthy KJ, Wang X, Vallejo J, Chow ECY, Li RJ, Sun J, et al. FDA approval summary: ivosidenib in combination with azacitidine for treatment of patients with newly diagnosed acute myeloid leukemia with an IDH1 mutation. Clin Cancer Res. 2023 Nov 27. Epub ahead of print. (Review of the data on safety and efficacy of the combination of ivosidenib and azacytidine as therapy for newly diagnosed AML in patients above the age of 75, found an improved overall survival with the combination of 24 vs 9 months with azacytidine alone, but similar rates of adverse events, with dose interruptions in 56%, dose modifications in 14%, and discontinuations in 31%, the major serious adverse events being differentiation syndrome and prolongation of the QTc interval; no mention of ALT elevations or hepatotoxicity). 38010220

## OTHER REFERENCE LINKS

Recent References on Ivosidenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ivosidenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Ivosidenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ivosidenib)